# Methimazole

## OVERVIEW

### Introduction

Methimazole is an antithyroid medication which is now considered the first line agent for medical therapy of hyperthyroidism and Graves disease. Methimazole has been linked to serum aminotransferase elevations during therapy as well as to a clinically apparent, idiosyncratic liver injury that is typically cholestatic and self-limited in course.

### Background

Methimazole (meth im' a zole), which is also known as thiamazole, is a thioamide and a thyroid hormone antagonist which acts by inhibiting the incorporation of iodine into tyrosyl residues of thyroglobulin and, thus, lowering thyroid hormone levels. Methimazole resembles propylthiouracil both in chemical structure and activity. Methimazole was introduced into use in 1954 and is still widely used for the temporary amelioration of hyperthyroidism in Graves disease, particularly in patients with mild or self-limited hyperthyroidism or who wish to avoid thyroidectomy or radiation therapy. Because of the hepatotoxicity of propylthiouracil which can be fatal, methimazole is now considered the first line treatment for hyperthyroidism when there is a need to avoid surgery or radioiodine therapy. Methimazole is available in generic forms and under the brand name of Tapazole as tablets of 5 and 10 mg. The usual dose in adults is 15 to 60 mg daily in three divided doses until the patient is euthyroid, followed by a maintenance dose of 5 to 15 mg daily. Common side effects include gastrointestinal upset, headache, drowsiness, arthralgias, paresthesias, hair loss and rash. Rare complications of methimazole (<1%) include agranulocytosis, aplastic anemia, nephritis and hepatitis.

### Hepatotoxicity

Methimazole has been associated with transient, asymptomatic elevations in serum aminotransferase levels, typically during the first 3 months after starting during high dose, induction therapy. These elevations are rarely clinically significant and usually resolve even with continuation of therapy. Methimazole is also capable of causing clinically apparent, idiosyncratic liver injury. The onset of hepatotoxicity is usually within 2 to 12 weeks of starting and the pattern of enzyme elevations is typically cholestatic or mixed, although hepatocellular patterns have also been described. The cholestatic hepatitis caused by methimazole can be prolonged, but fatalities are rare and symptoms and jaundice usually clear within 2 to 8 weeks of stopping therapy. Rare instances of prolonged cholestasis have been described, but no instance of vanishing bile duct syndrome.

Complicating the assessment of the role of methimazole or propylthiouracil in causing liver injury is the fact that hyperthyroidism by itself can cause liver test abnormalities and even jaundice. Indeed, more than half of patients with untreated hyperthyroidism have serum enzyme abnormalities (usually less than 5 times the upper limit of the normal range) and a small proportion are jaundiced and present with cholestatic hepatitis. The liver test elevations are most frequent in patients with high output heart failure. The abnormalities resolve rapidly with treatment of hyperthyroidism either with surgery, radioactive iodine or antithyroid medications.

Likelihood score: A (well known but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which methimazole causes acute liver injury is unknown, but is likely due to an immunological reaction to a metabolic product of its metabolism.

### Outcome and Management

The severity of methimazole induced liver injury varies from mild, transient serum aminotransferase elevations to moderately severe cholestatic hepatitis. Fatal cases are rare. Some cases have features of autoimmunity or immunoallergic hepatitis and have been treated with corticosteroids, but without proven evidence of benefit. Recovery is usually rapid once methimazole is stopped, and the first priority should be immediate discontinuation of antithyroid therapy at the first sign of clinically apparent liver disease. The presence of hyperthyroidism may play a role in worsening liver function, and temporary management with beta-blockers or other approaches may be necessary even during the course of the acute liver injury. In several instances, patients with methimazole induced liver injury have been switched to propylthiouracil without evidence of recurrence, but in at least one case, recurrent jaundice appeared. In severe cases, however, more definitive therapy of the hyperthyroidism with radioactive iodide or surgery may be more appropriate.

Drug Class: Antithyroid Agents

Other Drugs in the Class: Propylthiouracil

## CASE REPORT

### Case 1. Mixed cholestatic-hepatocellular injury due to methimazole.(1)

A 43 year old woman with Graves disease developed pruritus and jaundice one month after starting therapy with methimazole (10 mg) and propranolol (20 mg), both given three times daily. She did not have abdominal pain, nausea, fever or rash. She continued taking methimazole for 4 days after the appearance of jaundice and presented to the hospital two weeks later because of persistent jaundice and pruritus. She had no history of liver disease or alcohol abuse and no risk factors for viral hepatitis. She had been clinically hyperthyroid with palpitations, tremor and elevated serum T4 levels [30.7 μg/dL] before therapy and routine liver tests were mildly abnormal (Table). On presentation, she was jaundiced but had no signs of chronic liver disease. Laboratory testing showed elevations in serum direct and total bilirubin and a cholestatic pattern of enzyme elevations. CT imaging of the abdomen showed no evidence of biliary obstruction. Tests for hepatitis A, B and C and autoantibodies were negative. Propranolol therapy was restarted but methimazole was held. She improved and jaundice resolved within 4 weeks and other liver test abnormalities within 8 weeks. After recovery from the liver injury, her hyperthyroidism was treated successfully with radioactive iodine.

#### Key Points

Medication: | Methimazole (30 mg daily)
Pattern: | Cholestatic (R=0.6)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 month
Recovery: | 2 months
Other medications: | Amlodipine, propranolol (both continued)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 134 | 201 | 0.8
6 weeks | 14 days | 104 | 289 | 16.7 | Admission
| 15 days | 91 | 264 | 14.9
| 16 days | | | 13.3
| 18 days | 130 | 233 | 12.6
7 weeks | 20 days | 269 | 235 | 11.4
| 22 days | 248 | 209 | 8.8 | Discharge
8 weeks | 26 days | 151 | 150 | 4.7
12 weeks | 8 weeks | 63 | 154 | 1.6
5 months | 4 months | 66 | 111 | 0.6
Normal Values | | <75 | <116 | <1.2

#### Comment

Typical cholestatic hepatitis arising one month after starting therapy with methimazole. The patient was ill for almost two months but recovery was otherwise uncomplicated.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Methimazole – Tapazole®

DRUG CLASS

Antithyroid Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=METHIMAZOLE)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Methimazole | 60-56-0 | C4-H6-N2-S

## CITED REFERENCE

1 Mikhail NE. (2004). Methimazole-induced cholestatic jaundice. South Med J.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2020

Zimmerman HJ. Antithyroid drugs. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 579-81. (Expert review of hepatotoxicity of antithyroid medications published in 1999; mentions 35 recorded cases of jaundice attributed to propylthiouracil [usually hepatocellular] and 15 to methimazole [usually cholestatic]).
Chitturi S, Farrell GC. Antithyroid drugs. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 614-5. (Review of hepatotoxicity of antithyroid agents mentions that methimazole typically causes a cholestatic hepatitis arising within 2-12 weeks of starting and with "uneventful recovery").
Brent GA, Koenig RJ. Thyroid and anti-thyroid drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp.787-802. (Textbook of pharmacology and therapeutics).
Specht NW, Boehme EJ. (1952). Death due to agranulocytosis induced by methimazole therapy. JAMA. (67 year old woman developed fever 4 weeks after starting methimazole with agranulocytosis and jaundice, dying within 1-2 days; liver at autopsy showing “central congestion”).
Rosenbaum H, Reveno WS. (1953). Agranulocytosis and toxic hepatitis from methimazole. JAMA. (62 year old woman developed jaundice 7 weeks after starting methimazole followed by agranulocytosis, resolving rapidly with stopping methimazole; had tolerated propylthiouracil).
Shipp JC. (1955). Jaundice during methimazole (‘Tapazole’) administration. Ann Intern Med. (63 year old developed pruritus followed by jaundice 2 weeks after starting methimazole [bilirubin 8.7 mg/dL, Alk P 3 times ULN], with subsequent worsening of jaundice and agranulocytosis responding to antibiotics; resolution of jaundice in 10 weeks).
Tennenbaum JI, Dreskin OH. (1962). Toxic hepatitis during treatment with methimazole (Tapazole). Report of a case with apparent recovery. Ohio Med J. (38 year old woman developed rash, jaundice and pruritus ~4 weeks after starting methimazole [bilirubin 6.2 mg/dL, ALT 545 U/L, Alk P ~2 times ULN, 12% eosinophils], slowly resolving on stopping therapy).
Martinez-Lopez JI, Greenberg SE, Kling RR. (1962). Drug-induced hepatic injury during methimazole therapy. Gastroenterology. (36 year old woman developed jaundice and pruritus 1 month after starting methimazole [bilirubin 18 m/dL, Alk P 3 times ULN, AST 400 U/L, protime 18 sec]; she delayed in stopping methimazole and jaundice persisted for 10 weeks).
Greenberger NJ, Milligan FD, DeGroot LJ, Isselbacher KJ. (1964). Jaundice and thyrotoxicosis in the absence of congestive heart failure. A study of four cases. Am J Med. (Description of 4 patients with jaundice and hyperthyroidism with congestive heart failure, but not on therapy and with no other known cause of liver disease [bilirubin 1.3-6.4 mg/dL, Alk P 1-3 times ULN, AST 13-40 U/L], jaundice resolving with successful therapy of hyperthyroidism).
Sambe K. (1965). Liver injury due to drugs. Acta Hepatol (Japan). (Review of pathology of 19 cases of drug induced liver disease, one due to methylthioracil [similar to propylthiouracil, not used in US] and one to mercazol [carbimazole]; little clinical information given).
Becker CE, Gorden P, Robbins J. (1968). Hepatitis from methimazole during adrenal steroid therapy for malignant exophthalmos. JAMA. (54 year old woman on corticosteroids for severe exophthalmos developed jaundice 4 weeks after starting methimazole [bilirubin 5.1 mg/dL, ALT 414 U/L, Alk P 1.5 times ULN], switched to propylthiouracil and recovered promptly).
Fischer MG, Nayer HR, Miller A. (1973). Methimazole-induced jaundice. JAMA. (74 year old woman developed jaundice 2 weeks after starting methimazole [bilirubin 13.6 mg/dL, Alk P 270 U/L, ALT 96 U/L], jaundice lasted 2 months after stopping even with prednisone therapy).
Ishizuki Y. (1974). Horumon To Rinsho. (Two cases, ages 62 and 75 years, had onset of jaundice 3 and 5 weeks after starting antithyroid medications, with prolonged cholestasis in patient in whom methimazole was continued).
Kimura T, Shindo T. (1982). Nippon Naika Gakkai Zasshi.
Cooper DS. (1984). Antithyroid drugs. N Engl J Med. (Extensive review of mechanism of action, efficacy and safety of propylthiouracil and methimazole in treating hyperthyroidism; side effects occur in 1-5% of patients, including fever, rash, urticaria, transient leucopenia, and arthralgias particularly with higher doses; severe side effects include agranulocytosis, vasculitis, aplastic anemia, thrombocytopenia and nephritic syndrome).
Vitug AC, Goldman JM. (1985). Hepatotoxicity from antithyroid drugs. Horm Res. (Review of literature identified 29 cases of hepatic injury due to propylthiouracil [n=17], methimazole [n=10] and carbimazole [n=3]; propylthiouracil cases were predominantly hepatocellular with onset in 10 days to 5 months; liver injury from other agents was primarily cholestatic arising in 10 days to 8 weeks).
Schmidt G, Boerach G, Mueller KM, Wegener M. (1986). Methimazole associated cholestatic liver injury: case report and brief literature review. Hepato-gastroenterol. (58 year old woman developed abdominal pain 18 days after starting methimazole [bilirubin 1.2 mg/dL, ALT 93 U/L, Alk P 572 U/L], with improvement on stopping and recurrent rise in Alk P with rechallenge).
Yao JD, Gross JB, Ludwig J, Purnell DC. (1989). Cholestatic jaundice in hyperthyroidism. Am J Med. (42 year old man presented with jaundice and weight loss [bilirubin 16.7 rising to 36.0 mg/dL, ALT 76 U/L, Alk P 252 U/L] on no medications, liver biopsy showed intrahepatic cholestasis and he was found to be hyperthyroid, jaundice resolving after radioactive iodine therapy).
Baker B, Shapiro B, Fig LM, Woodbury D, Sisson JC, Beierwaltes WH. (1989). Unusual complications of antithyroid drug therapy: four case reports and review of literature. Thyroidology. (Three cases of hepatotoxicity from thyroid medications; 34 year old woman developed jaundice 6 months after starting propylthiouracil [bilirubin 20.6 mg/dL, ALT 957 U/L, Alk P 176 U/L], with delayed withdrawal and slow recovery; 9 year old girl developed jaundice 3 months after starting propylthiouracil [bilirubin 9.0 mg/dL, ALT 1407 U/L, Alk P 848 U/L], resolving rapidly upon stopping; 20 year old woman developed jaundice 8 months after starting methimazole [bilirubin 27 mg/dL, ALT 2040 U/L, Alk P 389 U/L], progressing to hepatic failure and death and autopsy showed massive necrosis).
Werner MC, Romaldini JH, Bromberg N, Werner RS, Farah CS. (1989). Adverse effects related to thioamide drugs and their dose regimen. Am J Med Sci. (Among 389 treated patients with Graves disease, 5 had hepatotoxicity, 4 of 131 [2%] on propylthiouracil and 1 of 258 [0.5%] on methimazole, all recovered; mostly on high dose therapy).
Kang H, Choi JD, Jung IG, Kim DW, Kim TB, Shin HK, et al. (1990). A case of methimazole-induced acute hepatic failure in a patient with chronic hepatitis B carrier. Korean J Intern Med. (43 year old man with HBsAg carrier state developed jaundice 7 months after starting methimazole [bilirubin 5.0 mg/dL, ALT 180 U/L, Alk P 848 U/L, no detectable HBV DNA], developed worsening hepatic failure and died 30 days after admission, autopsy showed cirrhosis with severe cholestasis).
Di Gregorio C, Ghini F, Rivasi F. (1990). Granulomatous hepatitis in a patient receiving methimazole. Ital J Gastroenterol. (56 year old woman developed abnormal liver tests 11 years after starting methimazole and not resolving when drug was stopped, biopsy showing active granulomas with giant cells suggestive of sarcoidosis [bilirubin normal, ALT 51-138 U/L, Alk P 484-652 U/L]).
Findor J, Bruch Igartúa E, Sorda J, Jury R. (1991). Acta Gastroenterol Latinoam.
Sola J, Pardo-Mindán FJ, Zozaya J, Quiroga J, Sangro B, Prieto J. (1991). Liver changes in patients with hyperthyroidism. Liver. (Four patients with thyrotoxicosis and “cholestasis” [bilirubin 0.8-1.0 mg/dL, Alk P 300-548 U/L, GGT 17-166 U/L], biopsies showing intrahepatic cholestasis).
Peter SA. (1991). Propylthiouracil-associated hepatitis. J Natl Med Assoc. (43 year old woman developed jaundice 10 weeks after starting propylthiouracil [bilirubin 6.4 mg/dL, AST 926 U/L, Alk P 292 U/L], worsening for 10 days and then resolving within 10 weeks of stopping).
Liaw YF, Huang MJ, Fan KD, Li KL, Wu SS, Chen TJ. (1993). Hepatic injury during propylthiouracil therapy in patients with hyperthyroidism. A cohort study. Ann Intern Med. (60 patients with hyperthyroidism and normal baseline ALT levels were monitored on propylthiouracil, 28% developed ALT elevations [40-231 U/L] all within 2 months of starting initial high dosage [300 mg/day], falling to normal with continuation [100 mg/day]; no symptoms, jaundice or Alk P elevations; liver biopsies in 3 patients showed spotty necrosis and ill defined granulomas).
Sadoul JL, Canivet B, Freychet P. (1993). Toxic hepatitis induced by antithyroid drugs: four cases including one with cross-reactivity between carbimazole and benzylthiouracil. Eur J Med. (Retrospective analysis of 236 patients with hyperthyroidism treated at one center found 4 cases [1.7%] with hepatotoxicity due to carbimazole; only one with jaundice [bilirubin 3.5 mg/dL, ALT 162 U/L, Alk P 318 U/L], resolution in 4 weeks of stopping; other cases anicteric and associated with drug fever or rash, largely cholestatic enzyme patterns).
Huang MJ, Li KL, Wei JS, Wu SS, Fan KD, Liaw YF. (1994). Sequential liver and bone biochemical changes in hyperthyroidism: prospective controlled follow-up study. Am J Gastroenterol. (Prospective study of 95 patients with hyperthyroidism treated with propylthiouracil; 76% had at least one liver test abnormality before therapy, 37% in ALT [peak 169 U/L] and 64% in Alk P [peak 337 U/L]; ALT levels often decreased with treatment, but rose further in 38%, one developing jaundice [ALT 1490 U/L], resolving with stopping therapy).
Mamianetti A, Muñoz A, Ronchetti RD, Maccione E, Poggi U, Mugnolo R, et al. (1995). Medicina (B Aires). (62 year old woman developed jaundice and pruritus within 10 days of starting methimazole [bilirubin 16 rising to 39 mg/dL, ALT 65 U/L, Alk P 670 U/L], with prolonged jaundice and sideroblastic anemia, resolving slowly with normal tests 14 months later).
Arab DM, Malatjalian DA, Rittmaster RS. (1995). Severe cholestatic jaundice in uncomplicated hyperthyroidism treated with methimazole. J Clin Endocrinol Metab. (48 year old man with hyperthyroidism and mild liver enzyme abnormalities developed jaundice and worsening pruritus 1 month after starting methimazole [bilirubin 30.1 mg/dL, AST 40 U/L, Alk P 475 U/L], improving with stopping methimazole and achieving euthyroidism with radioactive iodide).
Schwab GP, Wetscher GJ, Vogl W, Redmond E. (1996). Methimazole-induced cholestatic liver injury, mimicking sclerosing cholangitis. Langenbecks Arch Chir. (68 year old man developed jaundice and pruritus 2 months after starting methimazole [bilirubin 3.1 rising to 12.2 mg/dL, ALT 61 U/L, Alk P 530 U/L], resolving within 3 months of stopping and with thyroidectomy).
Deidiker R, deMello DE. (1996). Propylthiouracil-induced fulminant hepatitis: case report and review of the literature. Pediatr Pathol Lab Med. (13 year old girl developed jaundice 4 months after starting propylthiouracil [bilirubin 13.8 mg/dL, ALT 1716 U/L, Alk P not given, ANA 1:20], worsening and undergoing liver transplantation within 7 days, but dying postoperatively, explant showing massive necrosis and collapse).
Gürlek A, Cobankara V, Bayraktar M. (1997). Liver tests in hyperthyroidism: effect of antithyroid therapy. J Clin Gastroenterol. (At least one liver test abnormality was found in 60% of patients with hyperthyroidism before therapy; Alk P in 44% and ALT in 23%; often improving on propylthiouracil therapy, but 15% developed de novo ALT elevations by 6 weeks, although none were symptomatic, jaundiced or required dose modification).
Waseem M, Seshadri KG, Kabadi UM. (1998). Successful outcome with methimazole and lithium combination therapy for propylthiouracil-induced hepatotoxicity. Endocr Pract. (49 year old man developed nausea 2 months after starting propylthiouracil; at 4 months bilirubin was 20.4 mg/dL, ALT 1043 U/L, Alk P 186 U/L, values worsening for 1 month despite stopping and then slowly returning towards normal despite use of methimazole).
Hung YT, Yu WK, Chow E. (1999). Delayed cholestatic hepatitis due to methimazole. Hong Kong Med J. (71 year old woman developed jaundice a few weeks after stopping a 5 month course of methimazole with prolonged jaundice [bilirubin 40 mg/dL, ALT 40 U/L, Alk P 600 U/L], with slow recovery over more than 6 months).
Babini G, Gurioli L, Rizzi R, Bertello P. (1999). Appearance of severe jaundice after radiometabolical treatment of thyrotoxicosis. J Endocrinol Invest. (63 year old man developed jaundice 2 weeks after receiving radioactive iodine for toxic goiter [bilirubin 6.8 mg/dL, ALT 86, Alk P 426 U/L], worsening for 2 weeks and then slowly improving with methimazole therapy of the hyperthyroidism).
Woeber KA. (2002). Methimazole-induced hepatotoxicity. Endocr Pract. (36 year old woman developed pruritus and jaundice 3 weeks after starting methimazole [bilirubin 12.1 rising to 25.8 mg/dL, ALT 127 U/L, Alk P 265 U/L], with slow recovery and Alk P abnormalities for ~12 months).
Kontoleon P, Ilias I, Koutras DA, Kontogiannis D, Papapetrou PD. (2002). Successful treatment with carbimazole of a hyperthyroid pregnancy with hepatic impairment after propylthiouracil administration: a case report. Clin Exp Obstet Gynecol. (27 year old woman developed elevations in ALT [151 U/L], with normal bilirubin [0.5 mg/dL] after 12th week of pregnancy while on propylthiouracil, resolving within 10 days of switching to carbimazole).
Russo MV, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug induced liver injury in the United States. Liver Transpl. (Among 2291 liver transplants for acute liver failure done in the US between 1990 and 2002, 357 were attributed to medications, 53% to acetaminophen; in remaining 137 cases, most common agents were isoniazid [24; 17.5%], propylthiouracil [13; 9.5%], phenytoin [10; 7.3%], valproate [10; 7.3%], nitrofurantoin [7; 5%], herbals [7; 5%], ketoconazole [6; 4%] and disulfiram [6; 4%]; none due to methimazole).
Mikhail NE. (2004). Methimazole-induced cholestatic jaundice. South Med J. (43 year old woman developed jaundice and pruritus one month after starting methimazole [bilirubin 16.7 mg/dL, ALT 104 U/L, Alk P 289 U/L], resolving 4 months after stopping; review of literature found 20 cases, 18 in women, onset in 3 days to 3 months, largely cholestatic, no fatalities from liver disease, recurrence on rechallenge with methimazole or carbimazole: Case 1).
Piñero Madrona A, Pons Miñano JA, Madrid Conesa J, Parrilla Paricio P. (2004). Rev Clin Esp. (46 year old woman with subclinical hyperthyroidism developed arthralgias and malaise 6 days after starting methimazole [ALT 1280 U/L, Alk P 520 U/L with normal bilirubin], resolving within 2 weeks of stopping).
Casallo Blanco S, Valero MA, Marcos Sánchez F, de Matías Salces L, Blanco González JJ, Martín Barranco MJ. (2007). Gastroenterol Hepatol. (79 year old woman developed jaundice 1 month after starting methimazole [bilirubin 3.2 mg/dL, ALT 184 U/L, Alk P 574 U/L], with prompt improvement on stopping; then, 2 weeks after starting propylthiouracil, she redeveloped jaundice [bilirubin 5.5 mg/dL, ALT 448 U/L, Alk P 279 U/L], values normalizing within 2 months of stopping and with concurrent prednisone therapy).
Ramos-Bonner LS, Goldberg TH, Moyer S, Anastasopoulou C. (2007). Methimazole-induced cholestatic jaundice in an elderly hyperthyroid patient. Am J Geriatr Pharmacother. (76 year old woman developed jaundice and pruritus 6 weeks after starting methimazole [bilirubin 25.4 mg/dL, ALT 676 U/L, Alk P 620 U/L, INR 1.2], worsening for 5 days and then resolving slowly).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to propylthiouracil or methimazole).
Cooper DS, Rivkees SA. (2009). Putting propylthiouracil in perspective. J Clin Endocrinol Metab. (Editorial summarizing issues of hepatotoxicity of propylthiouracil, 33 publications of hepatotoxicity in adults and 14 in children with UNOS reporting 16 liver transplants for acute liver failure due to propylthiouracil in adults and 7 in children between 1990 and 2007. In contrast, methimazole can cause liver injury but fatalities are rare; these factors led to recommendations that methimazole be used instead of propylthiouracil, except in first trimester of pregnancy [or for intolerance], and when surgery or radioiodine are not an option).
Bahn RS, Burch HS, Cooper DS, Garber JF, Greenlee CM, Klein IL, et al. (2009). The role of propylthiouracil in the management of Graves’ disease in adults: report of a meeting jointly sponsored by the American Thyroid Association and the Food and Drug Administration. Thyroid. (In 2008, propylthiouracil was prescribed for 101,000 persons in the US, while UNOS has reported 16 liver deaths in adults and 7 in children from propylthiouracil since 1990; making the estimated fatality rate from acute liver failure due to propylthiouracil 1:10,000 in adults and as high as 1:2000 in children; for these reasons, propylthiouracil should not be considered the “first line” of treatment of Graves disease, methimazole being preferred except in first trimester of pregnancy).
Rivkees SA, Mattison DR. (2009). Propylthiouracil (PTU) hepatotoxicity in children and recommendations for discontinuation of use. Int J Pediatr Endocrinol. (Review of propylthiouracil induced liver injury; 29 cases reported in literature, 14 in children, 9 resulting in death [3 in children] and 3 in liver transplantation; in contrast, fatality or transplantation due to methimazole induced liver disease has not been reported; concluded that propylthiouracil should not be used as treatment of Graves disease in children).
Gallelli L, Staltari O, Palleria C, De Sarro G, Ferraro M. (2009). Hepatotoxicity induced by methimazole in a previously healthy patient. Curr Drug Saf. (54 year old man developed fever, rash and then jaundice arising 14 days after starting methimazole [bilirubin 4.4 mg/dL, ALT 55 U/L, Alk P 374 U/L, GGT 627 U/L], resolving rapidly with stopping methimazole).
Zhang M, Zhou H, He R, Di F, Yang L, Yang T. (2010). Steroids for the treatment of methimazole-induced severe cholestatic jaundice in a 74-year-old woman with type 2 diabetes. Endocrine. (74 year old woman developed jaundice and pruritus 1 month after starting methimazole [bilirubin 14.9 mg/dL, ALT 92 U/L, Alk P 301 U/L], resolving slowly and with 8 weeks of prednisone).
Livadas S, Xyrafis X, Economou F, Boutzios G, Christou M, Zerva A, Karachalios A, Palioura H, Palimeri S, Diamanti-Kandarakis E. (2010). Liver failure due to antithyroid drugs: report of a case and literature review. Endocrine. (34 year old woman developed pruritus 20 days after starting methimazole [bilirubin 2.4 rising to 3.6 mg/dL, ALT 141 to 1125 U/L, Alk P 189 to 396 U/L], resolving within 4 weeks of stopping).
Shen C, Zhao CY, Liu F, Wang YD, Yu J. (2010). Acute-on-chronic liver failure due to thiamazole in a patient with hyperthyroidism and trilogy of Fallot: case report. BMC Gastroenterol. (24 year old man developed jaundice 1 year after starting methimazole [bilirubin 34.3 mg/dL, ALT 75 U/L, Alk P 133 U/L, INR 2.3], with progression to hepatic failure and death 27 days after presentation).
Alvarez MP, Cano RL, Fernández CP, Méndez LF, García RG. (2010). Endocrinol Nutr. (Two cases; 71 and 52 year old women developed enzyme elevations 6 weeks after starting methimazole [bilirubin 0.8 and 0.9 mg/dL, ALT 102 and 546 U/L, Alk P 889 and 999 U/L], resolving within 2 and 4 months of stopping).
Rivkees SA, Szarfman A. (2010). Dissimilar hepatotoxicity profiles of propylthiouracil and methimazole in children. J Clin Endocrinol Metab. (Analysis of FDA adverse event reports between 1969 and 2008 showed a higher rate of severe liver injury due to propylthiouracil than methimazole in children; “We are unaware of reports of death and liver failure in children and adolescents taking methimazole”).
Malozowski S, Chiesa A. (2010). Propylthiouracil-induced hepatotoxicity and death. Hopefully, never more. J Clin Endocrinol Metab. (Editorial in response to Rivkees [2010] summarizing the factors that led to the recommendation that propylthiouracil be avoided in children and be considered a second line drug for treating hyperthyroidism in adults).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 5 due to propylthiouracil, but none to methimazole).
Sato H, Minagawa M, Sasaki N, Sugihara S, Kazukawa I, Minamitani K, Wataki K, et al. (2011). Comparison of methimazole and propylthiouracil in the management of children and adolescents with Graves' disease: efficacy and adverse reactions during initial treatment and long-term outcome. J Pediatr Endocrinol Metab. (Retrospective analysis of safety and efficacy of methimazole in 64 and propylthiouracil in 69 children with hyperthyroidism found similar response rates, but more frequent adverse events with initial high doses of propylthiouracil).
Yang J, Zhong J, Zhou LZ, Hong T, Xiao XH, Wen GB. (2012). Sudden onset agranulocytosis and hepatotoxicity after taking methimazole. Intern Med. (38 year old woman with hyperthyroidism developed agranulocytosis and liver test abnormalities within a week of starting methimazole [bilirubin 1.5 mg/dL, ALT 226 U/L, Alk P 143], resolving within a week of stopping methimazole and starting G-CSF).
Hackmon R, Blichowski M, Koren G. (2012). The safety of methimazole and propylthiouracil in pregnancy: a systematic review. J Obstet Gynaecol Can. (Systematic review of safety of propylthiouracil and methimazole during pregnancy concludes that propylthiouracil "has been associated with a rare but serious form of hepatic failure").
Otsuka F, Noh JY, Chino T, Shimizu T, Mukasa K, Ito K, Ito K, Taniyama M. (2012). Hepatotoxicity and cutaneous reactions after antithyroid drug administration. Clin Endocrinol (Oxf). (Among 391 patients with hyperthyroidism, ALT levels >2 times ULN occurred in 9% on methimazole vs 26% on propylthiouracil arising after 12 to 60 days, but "...no serious liver failure was observed").
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including two attributed to propylthiouracil, but none to methimazole).
Maciá-Bobes C, Ronzón-Fernández A, Macías-Robles MD, Fau-Cubero C. (2012). Farm Hosp. (75 year old woman with toxic nodular goiter and multiple drug allergies developed liver test abnormalities 6 weeks after starting methimazole [bilirubin normal, ALT 454 U/L, GGT 268 U/L, Alk P normal], resolving within a month of switching to carbimazole).
Regelmann MO, Miloh T, Arnon R, Morotti R, Kerkar N, Rapaport R. (2012). Graves disease presenting with severe cholestasis. Thyroid. (17 year old girl with acute hepatitis A and Graves disease developed marked cholestasis, which improved with therapy of hyperthyroidism).
Yoshihara A, Noh J, Yamaguchi T, Ohye H, Sato S, Sekiya K, Kosuga Y, et al. (2012). Treatment of graves' disease with antithyroid drugs in the first trimester of pregnancy and the prevalence of congenital malformation. J Clin Endocrinol Metab. (Among 5997 infants of Japanese women with thyrotoxicosis during the first trimester, congenital malformations were found in 4.1% of infants of 1231 methimazole treated, 1.9% of 1399 propylthiouracil treated and 2.1% of 1906 untreated mothers).
de Campos Mazo DF, de Vasconcelos GB, Pereira MA, de Mello ES, Bacchella T, Carrilho FJ, et al. (2013). Clinical spectrum and therapeutic approach to hepatocellular injury in patients with hyperthyroidism. Clin Exp Gastroenterol. (Among 7 patients with hyperthyroidism found to have liver disease, 2 were attributed to propylthiouracil hepatotoxicity, 2 to autoimmune hepatitis and 3 to the underlying hyperthyroidism, but none to methimazole).
Korelitz JJ, McNally DL, Masters MN, Li SX, Xu Y, Rivkees SA. (2013). Prevalence of thyrotoxicosis, antithyroid medication use, and complications among pregnant women in the United States. Thyroid. (Analysis of 4902 15-44 year old women with thyrotoxicosis during pregnancy in a health insurance database [2005-2009] found no increase in liver abnormalities or congenital defects associated with either propylthiouracil or methimazole therapy).
Andersen SL, Olsen J, Wu CS, Laurberg P. (2013). Birth defects after early pregnancy use of antithyroid drugs: a Danish nationwide study. J Clin Endocrinol Metab. (In a population based cohort study from Denmark, exposure to either methimazole or propylthiouracil during pregnancy was associated with an increased rate of birth defects, but not use of these agents before or after pregnancy).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to antithyroid medications).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, five [including 2 deaths] were attributed to propylthiouracil but none to methimazole).
Wang MT, Lee WJ, Huang TY, Chu CL, Hsieh CH. (2014). Antithyroid drug-related hepatotoxicity in hyperthyroidism patients: a population-based cohort study. Br J Clin Pharmacol. (Among 71,379 patients with hyperthyroidism initiating medical therapy between 2004 and 2009 identified in the Taiwanese National Health Insurance Research Database, methimazole/carbimazole had a higher rate of clinically apparent liver injury than propylthiouracil [3.2 vs 1.2] but a lower rate of acute liver failure [0.32 vs o.68: both per 1000-patient years]).
Akmal A, Kung J. (2014). Propylthiouracil, and methimazole, and carbimazole-related hepatotoxicity. Expert Opin Drug Saf. (Review of the hepatotoxicity of antithyroid medications concludes that methimazole and carbimazole are more likely to cause cholestatic liver injury, while propylthiouracil is more likely to cause acute liver failure for which reason its use should be limited to use in adults and in the first trimester of pregnancy and thyroid storm)
Heidari R, Niknahad H, Jamshidzadeh A, Abdoli N. (2014). Factors affecting drug-induced liver injury: antithyroid drugs as instances. Clin Mol Hepatol. (Review of risk factors associated with liver injury from methimazole and propylthiouracil including age, gender, alcohol use and co-morbidities, none of which appear to play a very major role).
Heidari R, Niknahad H, Jamshidzadeh A, Eghbal MA, Abdoli N. (2015). An overview on the proposed mechanisms of antithyroid drugs-induced liver injury. Adv Pharm Bull. (Review of the possible mechanisms of liver injury due to methimazole and propylthiouracil).
Papachristos DA, Huynh J, Grossman M, MacIsaac RJ. Liver dysfunction and anti-thyroid therapy. SAGE Open Med Case Rep 2015; 3: 2050313X14568335. (49 year old man with Graves disease developed jaundice 2 weeks after starting carbimazole [bilirubin 34 mg/dL, ALT 104 U/L, Alk P 147 U/L], which resolved within 3 months of stopping and after radioactive iodine treatment making it difficult to assess whether the injury was due to the medication versus hyperthyroidism).
Yang J, Li LF, Xu Q, Zhang J, Weng WW, Zhu YJ, Dong MJ. (2015). Analysis of 90 cases of antithyroid drug-induced severe hepatotoxicity over 13 years in China. Thyroid. (Among 90 patients with hyperthyroidism and drug induced liver injury due to antithyroid therapy seen at a single medical center over a 13 year period, 51 were attributed to methimazole [1 fatal] and 39 to propylthiouracil [none fatal]; both had similar latencies to onset [80% within 3 months, 60% within 1 month] and methimazole cases were more likely to be cholestatic [35% vs 18%] and less likely hepatocellular [43% vs 56%]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 [0.7%] were attributed to antithyroid drugs including 3 to methimazole [thiamazole], all of which were cholestatic or mixed and self-limited in course, and 3 to propylthiouracil, one of which was fatal and one occurring in a woman treated during pregnancy).
Ji H, Yue F, Song J, Zhou X. (2017). A rare case of methimazole-induced cholestatic jaundice in an elderly man of Asian ethnicity with hyperthyroidism: A case report. Medicine (Baltimore). (69 year old Asian man developed jaundice 3 weeks after starting methimazole for hyperthyroidism [bilirubin 21.6 mg/dL, ALT 59 U/L, Alk P 631 U/L], improving rapidly upon stopping).
Abramavicius S, Velickiene D, Kadusevicius E. (2017). Methimazole-induced liver injury overshadowed by methylprednisolone pulse therapy: Case report. Medicine (Baltimore). (74 year old woman with Graves disease and ophthalmopathy on methimazole therapy developed elevated ALT and AST levels after a 5^th^ weekly infusion of methylprednisolone, which gradually resolved despite continuing both drugs).
Forner D, Kulai T, Arnason T, E, Gruchy S, MacLeod M. (2017). Ramipril-associated cholestasis in the setting of recurrent drug-induced liver injury. Gastroenterol Hepatol Bed Bench. (67 year old man had two episodes of suspected drug induced liver injury, one due to methimazole and another 20 years later to ramipril, both being cholestatic and self-limited in course).
Jin S, Li X, Fan Y, Fan X, Dai Y, Lin H, Cai W, et al. (2019). Association between genetic polymorphisms of SLCO1B1 and susceptibility to methimazole-induced liver injury. Basic Clin Pharmacol Toxicol. (Several polymorphisms of SLCOB1 [the gene that encodes the organic anion-transporting peptide B1] were found more frequent among 44 patients with Graves disease who developed methimazole induced liver injury than in 118 Graves disease patients who did not).
Li X, Jin S, Fan Y, Fan X, Tang Z, Cai W, Yang J, et al. (2019). Association of HLA-C*03:02 with methimazole-induced liver injury in Graves' disease patients. Biomed Pharmacother. (Analysis of HLA class I and II alleles in patients with Graves disease who developed methimazole hepatotoxicity [n=40] or not [n=118], the allele frequency of HLA-C*03.02 was 6.7% in patients with methimazole hepatotoxicity compared to 0.4% of those who tolerated the drug without liver injury).
Suzuki N, Noh JY, Hiruma M, Kawaguchi A, Morisaki M, Ohye H, Suzuki M, et al. (2019). Analysis of antithyroid drug-induced severe liver injury in 18,558 newly diagnosed patients with Graves' disease in Japan. Thyroid. (Among 18,558 Japanese patients initiating medical therapy of Graves disease between 2005 and 2017, 416 [2.5%] developed evidence of liver injury [ALT above 8 times ULN or bilirubin above 3 times ULN], 1.4% on methimazole and 6.3% of propylthiouracil, 92% were women, onset usually within 30 days, rates being age-dependent and all patients recovered).

## OTHER REFERENCE LINKS

1 Recent References on Methimazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(methimazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/2/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Methimazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=methimazole)